# Darolutamide

## OVERVIEW

### Introduction

Darolutamide is a third generation, oral nonsteroidal antiandrogen used to treat nonmetastatic castration-resistant prostate cancer. Darolutamide is associated with a low rate of serum enzyme elevation during therapy, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Darolutamide (dar” oh loo' ta mide) is a small molecule androgen receptor antagonist which binds to the intracellular receptor and prevents its translocation to the nucleus and subsequent DNA binding, thereby blocking its activity. Therapy with darolutamide lowers residual testosterone levels after surgical castration in men with prostate cancer and has been shown to prolong metastatic free survival in castration-resistant prostate cancer patients with rising levels of prostate-associated antigen (PSA) without measurable metastatic disease. Darolutamide was approved for use in the United States in 2019 and is available as 300 mg tablets under brand name Nubeqa. The recommended initial dose is 600 mg (two tablets) twice daily. Darolutamide should be used in combination with testosterone suppression either with a gonadotrophin releasing hormone (GnRH) analogue or after bilateral orchiectomy to insure optimal androgen suppression. Common side effects include symptoms of androgen deficiency including fatigue, diarrhea, nausea, anorexia, weight loss, constipation, joint and muscle pain, hot flushes, headaches, dizziness, and edema. Rare, but potentially serious side effects associated with long term therapy include seizures, osteoporosis, bone fractures, and cardiovascular events.

### Hepatotoxicity

In prelicensure controlled trials with 1508 patients, serum AST elevations were more common with darolutamide than placebo therapy [23% vs 14%], but were rarely above 5 times the ULN [<1%] and ALT elevations were uncommon, although the results were not provided. Similarly, serum bilirubin levels were more frequently elevated on darolutamide therapy than placebo [16% vs 7%] but were rarely markedly elevated [less than 0.5%], and there were no cases of clinically apparent liver injury. Since approval and general availability of darolutamide, there have been no published reports of liver injury attributed to darolutamide therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum AST and bilirubin elevations that occur during darolutamide therapy is unknown. Darolutamide is extensively metabolized in the liver predominantly by CYP 3A4. Its use with strong inducers of CYP 3A4 could result in decreased drug levels and reduced efficacy, while use with strong CYP 3A4 inhibitors could result in elevated drug levels and potentially increased adverse events.

### Outcome and Management

The elevations in serum AST and bilirubin during darolutamide therapy have been asymptomatic, mild and transient, not requiring dose adjustments. Routine monitoring of liver tests is not recommended, but finding AST elevations above 5 times the upper limit of normal would warrant search for another cause of liver injury and stopping therapy or modifying the dose if no other cause is found. There is no information on cross sensitivity for hepatic injury between darolutamide and other antiandrogens, such as flutamide, bicalutamide, apalutamide, enzalutamide, or abiraterone.

Drug Class: Antineoplastic Agents, Antiandrogens

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Darolutamide – Nubeqa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Darolutamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Darolutamide | 1297538-32-9 | C19-H19-Cl-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2023

Abbreviations: PSA, prostate-specific antigen; LHRH, luteinizing hormone releasing hormone.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of antineoplastic antiandrogens such as darolutamide).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; darolutamide is not discussed).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-48. (Textbook of pharmacology and therapeutics discusses the androgen receptor antagonists flutamide, bicalutamide, nilutamide and enzalutamide, but not apalutamide or darolutamide).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212099Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that AST elevations were more frequent on darolutamide than placebo [23% vs 14%] as were bilirubin elevations [16% vs 7%], but that other liver test abnormalities were uncommon, and there were no cases of clinically apparent liver injury with jaundice).
Tran C, Ouk S, Clegg NJ, Chen Y, Watson PA, Arora V, Wongvipat J, et al. (2009). Development of a second-generation antiandrogen for treatment of advanced prostate cancer. Science. (Description of development of unique antiandrogen molecules that block the translocation of the androgen receptor to the nucleus and the transcriptional activity of the receptor).
Fizazi K, Massard C, Bono P, Jones R, Kataja V, James N, Garcia JA, et al., ARADES study group. (2014). Activity and safety of ODM-201 in patients with progressive metastatic castration-resistant prostate cancer (ARADES): an open-label phase 1 dose-escalation and randomised phase 2 dose expansion trial. Lancet Oncol. (Among 110 patients with castration-resistant, metastatic prostate cancer treated with 200, 400 or 1400 mg of darolutamide daily, PSA response rates were similar in all three doses and adverse events included fatigue [31%], back pain [21%], arthralgia [15%] and pain [15%]; no mention of ALT elevations or hepatotoxicity).
Fizazi K, Massard C, Bono P, Kataja V, James N, Tammela TL, Joensuu H, et al. (2017). Safety and antitumour activity of ODM-201 (BAY-1841788) in castration-resistant, CYP17 inhibitor-naïve prostate cancer: results from extended follow-up of the ARADES trial. Eur Urol Focus. (Among 41 patients with castration-resistant prostate cancer participating in preliminary trials of darolutamide who were enrolled in open label extension studies, results after 15 months of follow up showed continued antitumor activity and continued rates of mild-to-moderate adverse events; no mention of ALT elevations or hepatotoxicity).
Crawford ED, Schellhammer PF, McLeod DG, Moul JW, Higano CS, Shore N, Denis L, et al. (2018). Androgen receptor targeted treatments of prostate cancer: 35 years of progress with antiandrogens. J Urol. (Review of the development of antiandrogen therapies of prostate cancer starting with discovery of the androgen sensitive nature of prostate cancer, the effects of orchiectomy, followed by the development of androgen receptor antagonists, first generation agents flutamide and nilutamide, second generation agent bicalutamide and third generation agents enzalutamide, apalutamide and darolutamide that have more potent androgen receptor inhibition).
(2019). Darolutamide (Nubeqa) for prostate cancer. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of darolutamide shortly after its approval for use in the US, mentions side effects of fatigue, pain, rash, neutropenia and elevations in AST and bilirubin without mention of hepatotoxicity).
Fizazi K, Shore N, Tammela TL, Ulys A, Vjaters E, Polyakov S, Jievaltas M, et al. (2020). ARAMIS Investigators. Nonmetastatic, castration-resistant prostate cancer and survival with darolutamide. N Engl J Med. (Among 1509 men with non-metastatic, castration-resistant prostate cancer treated in a controlled trial for a median of 29 months, metastasis free survival was longer and risk of death lower with darolutamide than placebo treatment; adverse events that were more frequent with active drug included fatigue, pain and rash; no mention of ALT elevations or hepatotoxicity).
Halabi S, Jiang S, Terasawa E, Garcia-Horton V, Ayyagari R, Waldeck AR, Shore N. (2021). Indirect comparison of darolutamide versus apalutamide and enzalutamide for nonmetastatic castration-resistant prostate cancer. J Urol. (Comparison of outcome and adverse events in published randomized, placebo-controlled trials of darolutamide, apalutamide and enzalutamide for castration-resistant prostate cancer suggested that efficacy as assessed by improvement in metastasis-free survival was similar for all three agents, but that darolutamide therapy was associated with lower rates of adverse events, particularly fatigue, rash, falls, seizures, fractures and cognitive disorders; no mention of ALT elevations or hepatotoxicity).
Gillessen S, Procopio G, Hayoz S, Kremer E, Schwitter M, Caffo O, Lorente D, et al. (2023). Darolutamide maintenance in patients with metastatic castration-resistant prostate cancer with nonprogressive disease after taxane treatment (SAKK 08/16). J Clin Oncol. (Among 92 patients with metastatic, castration-resistant prostate cancer treated with addition of darolutamide or placebo, radiologic progression free survival was 5.5 months with darolutamide vs 4.5 months with placebo and overall adverse event rates were similar, although fatigue was less with darolutamide [11% vs 20%]; no mention of ALT elevation or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Darolutamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Darolutamide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Darolutamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Darolutamide)